# Pemetrexed

## OVERVIEW

### Introduction

Pemetrexed is a parenterally administered folate antagonist and antineoplastic agent, used in the treatment of non-small cell lung cancer and malignant mesothelioma. Pemetrexed therapy has been associated with moderate rates of serum enzyme elevations during therapy, but has not been convincingly linked to instances of acute, clinically apparent liver injury.

### Background

Pemetrexed (pem" e trex' ed) is a folic acid analog which acts as an antagonist to the enzymes involved in folate dependent synthetic pathways such as thymidine synthase, dihydrofolate reductase and glycinamide ribonucleotide formyltransferase. Inhibition of these enzymes leads to decrease in intracellular thymidine and purine which interferes with DNA synthesis and leads to apoptotic cell death in rapidly dividing cells. In vitro and in vivo studies have shown that pemetrexed inhibits growth of mesothelioma and non-small cell lung cancer cell lines, and clinical trials in advanced forms of these cancers have shown improvements in overall survival times in pemetrexed treated subjects. Pemetrexed was approved for use in the United States in 2004. Current indications are for locally advanced or metastatic nonsquamous, non-small cell lung cancer (NSCLC) and for malignant pleural mesothelioma, usually in combination with other antineoplastic agents (such as cisplatin) and with folic acid and vitamin B12 supplementation. Pemetrexed is available in single use vials of 100 or 500 mg as a powder for reconstitution under the brand name Alimta. The recommended dose is 500 mg/m^2^ intravenously on day 1 of each 21 day cycle. Pemetrexed shares common side effects with other folate antagonists such as fatigue, nausea, vomiting, anorexia, diarrhea, alopecia, bone marrow suppression, and rash. Uncommon, but potentially serious adverse events include febrile neutropenia, infections, dehydration, renal failure, arrhythmias and peripheral neuropathy.

### Hepatotoxicity

Pemetrexed therapy is associated with a low-to-moderate rate of serum enzyme elevations, but these are generally mild, transient and without accompanying symptoms or jaundice. Serum ALT or AST elevations above 5 times ULN occur in 1% to 6% of patients, but are usually self-limited in course and rarely require dose modification or discontinuation. No instances of clinically apparent acute liver injury attributed to pemetrexed have been reported. In addition, pemetrexed has not been linked to sinusoidal obstruction syndrome or to reactivation of hepatitis B, but it is rarely used in high doses in neoplastic disease or in conditioning regimens for bone marrow transplantation, situations in which other neoplastic agents are commonly associated with these complications.

Likelihood score: E* (unlikely but suspected cause of liver injury).

### Mechanism of Injury

The cause of the serum enzyme elevations that may occur during pemetrexed use is probably direct hepatotoxicity from the folate antagonism. Its hepatic metabolism is minimal and most of the administered dose is excreted unchanged in the urine.

### Outcome and Management

Liver injury is rare after pemetrexed therapy. Persistent serum enzyme elevations above 5 times ULN should lead to temporary discontinuation of pemetrexed therapy, but should also lead to careful search for other possible causes of liver injury. There have been no instances of acute liver failure, chronic hepatitis or vanishing bile duct syndrome linked to pemetrexed therapy.

Drug Class: Antineoplastic Agents, Antifolate Agents

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Pemetrexed – Alimta®

DRUG CLASS

Antineoplastic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Pemetrexed)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Pemetrexed | 150399-23-8 | C20-H21-N5-O6.2Na | Pemetrexed chemical structure
Folate | 6484-89-5 | C19-H18-N7-O6.Na | Folate chemical structure

## ANNOTATED BIBLIOGRAPHY

References updated: 18 April 2016

Zimmerman HJ. Oncotherapeutic and immunosuppressive agents. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 673-708. (Expert review of hepatotoxicity of cancer chemotherapeutic agents published in 1999; pemetrexed is not discussed).
DeLeve LD. Cancer chemotherapy. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 549-68. (Review of hepatotoxicity of cancer chemotherapeutic agents; pemetrexed is not discussed).
Chabner BA, Bertino J, Clearly J, Ortiz T, Lane A, Supko JG, Ryan DP. Folic acid analogs. Cytotoxic agents. Chemotherapy of neoplastic diseases. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 1690-94. (Textbook of pharmacology and therapeutics).
Rusthoven JJ, Eisenhauer E, Butts C, Gregg R, Dancey J, Fisher B, Iglesias J. Multitargeted antifolate LY231514 as first-line chemotherapy for patients with advanced non-small-cell lung cancer: A phase II study. National Cancer Institute of Canada Clinical Trials Group. J Clin Oncol 1999; 17: 1194. (Among 33 patients with NSCLC treated with pemetrexed [500-600 mg/m^2^ iv every 3 weeks], partial responses occurred in 23%, but there was a high rate of adverse events including fatigue in 80%, rash 79%, anorexia 67%, diarrhea 42% and AST elevations in 84% which were above 5 times ULN in 6%). 10561178
Clarke SJ, Abratt R, Goedhals L, Boyer MJ, Millward MJ, Ackland SP. Phase II trial of pemetrexed disodium (ALIMTA, LY231514) in chemotherapy-naïve patients with advanced non-small-cell lung cancer. Ann Oncol 2002; 13: 737-41. (Among 55 patients with NSCLC treated with pemetrexed [600 mg/m^2^ iv every 3 weeks], overall response rate was 15% and side effects were common, rash in 83%, nausea 76%, fatigue 56%, mucositis 44%, diarrhea 37% and ALT or AST elevations in 80% which were above 5 times ULN in 20%, but abnormalities often improved despite continuing therapy and no patient required drug discontinuation for liver related abnormalities). 12075742
Scagliotti GV, Shin DM, Kindler HL, Vasconcelles MJ, Keppler U, Manegold C, Burris H, et al. Phase II study of pemetrexed with and without folic acid and vitamin B12 as front-line therapy in malignant pleural mesothelioma. J Clin Oncol 2003; 21: 1556-61. (Among 64 patients with malignant pleural mesothelioma treated with pemetrexed [500 mg/m2 iv every 3 weeks], the response rate was 14% and ALT values above 5 times ULN occurred in 3.1%). 12697881
Cohen MH, Johnson JR, Wang YC, Sridhara R, Pazdur R. FDA drug approval summary: pemetrexed for injection (Alimta) for the treatment of non-small cell lung cancer. Oncologist 2005; 10: 363-8. (Summary of clinical evidence in support of FDA approval of pemetrexed for NSCLC; in a trial of 571 patients treated with pemetrexed or docetaxel, mean survival time and response rates were similar, while pemetrexed treated subjects had lower rates of neutropenia [11% vs 45%] and infections [31% vs 33%], but higher rates of ALT elevations [10% vs 2%] including those above 5 times ULN in [3% vs <1%]). 15967829
Hazarika M, White RM Jr, Booth BP, Wang YC, Ham DY, Liang CY, Rahman A, et al. Pemetrexed in malignant pleural mesothelioma. Clin Cancer Res 2005; 11: 982-92. (Summary of clinical evidence in support of FDA approval of pemetrexed for malignant mesothelioma; in a trial of 448 patients treated with cisplatin alone or in combination with pemetrexed, median survival time increased from 9.3 to 12.1 months with addition of the antifolate; AST elevations occurred in 8.3% on pemetrexed [none above 5 times ULN] and cisplatin and in 8.6% on cisplatin alone). 15709163
Jänne PA, Wozniak AJ, Belani CP, Keohan ML, Ross HJ, Polikoff JA, Mintzer DM, et al.; Pemetrexed expanded access program investigators. Pemetrexed alone or in combination with cisplatin in previously treated malignant pleural mesothelioma: outcomes from a phase IIIB expanded access program. J Thorac Oncol 2006; 1: 506-12. (Among 187 patients with mesothelioma enrolled in an expanded access program, overall response rate was 32.5% with the combination of cisplatin and pemetrexed vs only 5.5% with pemetrexed alone; adverse reactions included dehydration, nausea and pulmonary embolism; no mention of ALT elevations or hepatotoxicity). 17409909
Llombart-Cussac A, Martin M, Harbeck N, Anghel RM, Eniu AE, Verrill MW, Neven P, et al. A randomized, double-blind, phase II study of two doses of pemetrexed as first-line chemotherapy for advanced breast cancer. Clin Cancer Res 2007; 13: 3652-9. (Among 92 women with advanced breast cancer treated with pemetrexed [600 or 900/m^2^ every 3 weeks], response rates were 17% and 16% and side effects included ALT elevations above 5 times ULN in 2.1% and 4.4%). 17575230
Taylor P, Castagneto B, Dark G, Marangolo M, Scagliotti GV, van Klaveren RJ, Labianca R, et al. Single-agent pemetrexed for chemonaïve and pretreated patients with malignant pleural mesothelioma: results of an International Expanded Access Program. J Thorac Oncol 2008; 3: 764-71. (Among 812 patients with mesothelioma treated with pemetrexed in an open access program, partial responses occurred in 10% to 12% of patients and deaths attributed to adverse events in 1.5%; liver test elevations were not recorded). 18594323
Kuribayashi K, Voss S, Nishiuma S, Arakawa K, Nogi Y, Mikami K, Kudoh S. Safety and effectiveness of pemetrexed in patients with malignant pleural mesothelioma based on all-case drug-registry study. Lung Cancer 2012; 75: 353-9. (Among 903 Japanese patients with mesothelioma monitored in a registry of pemetrexed treated subjects, the overall response rate was 25%, and 1.5% developed interstitial lung disease; no mention of ALT elevations or clinically apparent liver injury). 21890228
Gridelli C, de Marinis F, Pujol JL, Reck M, Ramlau R, Parente B, Pieters T, et al. Safety, resource use, and quality of life in paramount: a phase III study of maintenance pemetrexed versus placebo after induction pemetrexed plus cisplatin for advanced nonsquamous non-small-cell lung cancer. J Thorac Oncol 2012; 7: 1713-21. (Among 539 patients with NSCLC treated with maintenance pemetrexed or placebo, adverse events that were more frequent with pemetrexed included fatigue [16% vs 11%], anorexia [4.3% vs 0.5%], nausea [12% vs 2%] and stomatitis [5% vs 2%]; ALT levels not mentioned). 23059776
Paz-Ares LG, de Marinis F, Dediu M, Thomas M, Pujol JL, Bidoli P, Molinier O, et al. PARAMOUNT: Final overall survival results of the phase III study of maintenance pemetrexed versus placebo immediately after induction treatment with pemetrexed plus cisplatin for advanced nonsquamous non-small-cell lung cancer. J Clin Oncol 2013; 31: 2895-902. (Among 939 patients with NSCLC treated with an induction regimen of pemetrexed with cisplatin followed by maintenance pemetrexed vs placebo, median overall survival time was 13.9 vs 11.0 months, while ALT elevations were more frequent with pemetrexed [any elevation in 2.5% vs 0.6%, above 5 times ULN in 0.3% vs 0%]). 23835707
Pujol JL, Paz-Ares L, de Marinis F, Dediu M, Thomas M, Bidoli P, Corral J, et al. Long-term and low-grade safety results of a phase III study (PARAMOUNT): maintenance pemetrexed plus best supportive care versus placebo plus best supportive care immediately after induction treatment with pemetrexed plus cisplatin for advanced nonsquamous non-small-cell lung cancer. Clin Lung Cancer 2014; 15: 418-25. (Among 539 patients with NSCLC given maintenance treatment with pemetrexed or placebo, ALT elevations occurred in 2.8% vs 0.6% and were above 5 times ULN in 0.3% vs 0%). 25104617

## OTHER REFERENCE LINKS

1. Recent References on Pemetrexed: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Pemetrexed+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Pemetrexed: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Pemetrexed)